# Siltuximab

## OVERVIEW

### Introduction

Siltuximab is a chimeric human-mouse monoclonal antibody to interleukin-6 which is used in the therapy of Castleman disease. Siltuximab commonly causes mild serum aminotransferase elevations which are usually short lived and asymptomatic, but it has not been linked to instances of clinically apparent liver injury with jaundice.

### Background

Siltuximab (sil tux' i mab) is human-mouse chimeric IgG1 monoclonal antibody to IL-6 that is used largely as therapy of autoinflammatory diseases such as Castleman disease. Siltuximab binds to and blocks the action of IL-6, which is a key proinflammatory cytokine that mediates a wide spectrum of biologic activities including activation of T cells, differentiation of B cells, induction of acute phase reactants, proliferation of fibroblasts, and damage to cartilage and joints. IL-6 levels are elevated in patients with autoinflammatory conditions and in some forms of cancer. In controlled trials and open label studies, siltuximab therapy led to improvements in symptoms and laboratory abnormalities associated with Castleman disease. It has also been used in chemotherapy of prostate cancer and multiple myeloma, but with only limited effects. Siltuximab was approved for use in the United States in 2014 and current indications are limited to adults or children above the age of 12 with multicentric Castleman disease. Siltuximab is given by intravenous infusion every 3 weeks, in doses of 11 mg/kg. Siltuximab is available as lyophilized powder in single use vials of 100 and 400 mg under the brand name Sylvant. The most frequent side effects are itching, weight gain, rash, upper respiratory symptoms, headache, fatigue, diarrhea, infusion reactions and hyperuricemia. Rare, but potentially severe adverse reactions include worsening of severe infections, infusion reactions and gastrointestinal perforation.

### Hepatotoxicity

In clinical trials of siltuximab combined with conventional chemotherapeutic agents in treatment of cancer, serum aminotransferase elevations occurred in a high proportion (10% to 30%) of patients. These trials included mention of some patients with elevations of ALT levels above 5 times the upper limit of normal and at least one example of reactivation of hepatitis B in a patient with multiple myeloma who also received dexamethasone. In studies of Castleman disease, however, rates of ALT elevations were usually not mentioned, although one instance of values above 5 times ULN were reported in one series. In these trials, no patient developed clinically apparent liver injury attributable to siltuximab. Since its licensure and general availability, there have been no published reports of hepatotoxicity due to siltuximab. Thus, siltuximab must be a rare cause of clinically apparent liver injury, if it occurs at all.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

Siltuximab is a monoclonal antibody and is metabolized by many tissues into smaller polypeptides and amino acids. The mechanism by which it might cause liver injury is unknown, but it could possibly cause liver injury as a result of its effects on the immune system or on the IL-6 pathway which is important in liver regeneration. Siltuximab may be capable of causing reactivation chronic hepatitis B.

### Outcome and Management

The serum enzyme elevations that have occurred during siltuximab therapy have been without symptoms or jaundice and short lived, resolving within a few weeks even without dose adjustment or discontinuation. There is no reason to suspect cross sensitivity to hepatic injury between siltuximab and other monoclonal antibodies known to cause liver injury such as infliximab and adalimumab.

Drug Class: Monoclonal Antibodies; Immunosuppressive Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Siltuximab – Sylvant®

DRUG CLASS

Immunosuppressive Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Siltuximab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Siltuximab | 541502-14-1 | Monoclonal Antibody | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 09 April 2016

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-53. (Expert review of hepatotoxicity published in 1999 before the availability of siltuximab and other monoclonal antibodies and anticytokines).
Krensky AM, Bennett WM, Vincenti F. Immunosuppressants, tolerogens, and immunostimulants. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1005-29. (Textbook of pharmacology and therapeutics).
Fizazi K, De Bono JS, Flechon A, Heidenreich A, Voog E, Davis NB, Qi M, et al. Randomised phase II study of siltuximab (CNTO 328), an anti-IL-6 monoclonal antibody, in combination with mitoxantrone/prednisone versus mitoxantrone/prednisone alone in metastatic castration-resistant prostate cancer. Eur J Cancer 2012; 48: 85-93. (Among 97 patients with advanced prostate cancer treated with siltuximab or placebo with mitoxantrone and prednisone, survival rates were similar, but adverse events were greater in the siltuximab group; no mention of ALT elevations or hepatotoxicity). 22129890
Dorff TB, Goldman B, Pinski JK, Mack PC, Lara PN Jr, Van Veldhuizen PJ Jr, Quinn DI, et al. Clinical and correlative results of SWOG S0354: a phase II trial of CNTO328 (siltuximab), a monoclonal antibody against interleukin-6, in chemotherapy-pretreated patients with castration-resistant prostate cancer. Clin Cancer Res 2010; 16: 3028-34. (Among 53 patients with refractory prostate cancer treated with siltuximab, clinical responses were infrequent and 1 patient developed ALT elevations above 5 times ULN). 20484019
San-Miguel J, Bladé J, Shpilberg O, Grosicki S, Maloisel F, Min CK, Polo Zarzuela M, et al. Phase 2 randomized study of bortezomib-melphalan-prednisone with or without siltuximab (anti-IL-6) in multiple myeloma. Blood 2014; 123: 4136-42. (Among 106 patients with refractory multiple myeloma treated with bortezomib, melphalan and prednisone, overall and progression-free survival was not different with the addition of siltuximab and side effects of neutropenia and thrombocytopenia were more common; no mention of ALT elevations or hepatotoxicity). 24833354
Angevin E, Tabernero J, Elez E, Cohen SJ, Bahleda R, van Laethem JL, Ottensmeier C, et al. A phase I/II, multiple-dose, dose-escalation study of siltuximab, an anti-interleukin-6 monoclonal antibody, in patients with advanced solid tumors. Clin Cancer Res 2014; 20: 2192-204. (Among 84 patients with advanced solid tumors treated with escalating doses of siltuximab, hepatic function abnormalities were reported in 15% of patients, but details were not given). 24563479
Voorhees PM, Manges RF, Sonneveld P, Jagannath S, Somlo G, Krishnan A, Lentzsch S, et al. A phase 2 multicentre study of siltuximab, an anti-interleukin-6 monoclonal antibody, in patients with relapsed or refractory multiple myeloma. Br J Haematol 2013; 161: 357-66. (Among 53 patients with refractory multiple myeloma treated with siltuximab with or without dexamethasone, frequent side effects included hepatic dysfunction [31%], enzyme elevations [16%] and one case of HBV reactivation [2%]; but no details provided). 23432640
Garcia-Manero G, Gartenberg G, Steensma DP, Schipperus MR, Breems DA, de Paz R, Valcárcel D, et al. A phase 2, randomized, double-blind, multicenter study comparing siltuximab plus best supportive care (BSC) with placebo plus BSC in anemic patients with International Prognostic Scoring System low- or intermediate-1-risk myelodysplastic syndrome. Am J Hematol 2014; 89: E156-62. (Among 76 patients with anemia due to myelodysplastic syndromes treated with siltuximab or placebo for 12 weeks, reduced red cell transfusion requirements occurred in 12% vs 4% and adverse events were frequent including “abnormal hepatic function” in 10% vs 12%; no details given). 24888488
van Rhee F, Wong RS, Munshi N, Rossi JF, Ke XY, Fosså A, Simpson D, et al. Siltuximab for multicentric Castleman's disease: a randomised, double-blind, placebo-controlled trial. Lancet Oncol 2014; 15: 966-74. (Among 89 patients with Castleman disease treated with siltuximab or placebo [11 mg/kg every 3 weeks], durable tumor and symptomatic responses occurred in 34% vs 0% while side effects included pruritus [42% vs 12%], fatigue [34% vs 38%], edema [32% vs 23%], weight gain [21% vs 0%], abdominal pain, thrombocytopenia; no mention of ALT or hepatotoxicity). 25042199
Orlowski RZ, Gercheva L, Williams C, Sutherland H, Robak T, Masszi T, Goranova-Marinova V, et al. A phase 2, randomized, double-blind, placebo-controlled study of siltuximab (anti-IL-6 mAb) and bortezomib versus bortezomib alone in patients with relapsed or refractory multiple myeloma. Am J Hematol 2015; 90: 42-9. (Among 281 patients with refractory multiple myeloma treated with siltuximab or placebo combined with bortezomib, addition of siltuximab was not associated with improved progression free survival, but was associated with increased rates of neutropenia and thrombocytopenia, and slight increases in ALT and AST were observed on day 1 of cycle 2 in both groups, “but mean values remained in the normal range throughout the randomized treatment phase”). 25294016
Deisseroth A, Ko CW, Nie L, Zirkelbach JF, Zhao L, Bullock J, Mehrotra N, et al. FDA approval: siltuximab for the treatment of patients with multicentric Castleman disease. Clin Cancer Res 2015; 21: 950-4. (Review of the clinical trial results that were the basis for approval of siltuximab as therapy of Castleman disease; no mention of ALT elevations or hepatotoxicity). 25601959
Siltuximab (Sylvant) for treatment of multicentric Castleman's disease. Med Lett Drugs Ther 2015; 57 (1459): e8 (Concise review of the mechanism of action, clinical efficacy, adverse effects and costs of siltuximab shortly after its approval in the US for Castleman disease mentions adverse events of rash, pruritus, weight gain, hyperuricemia and nasopharyngitis, but does not mention ALT elevations or hepatotoxicity). 25555075
van Rhee F, Casper C, Voorhees PM, Fayad LE, van de Velde H, Vermeulen J, Qin X, et al. A phase 2, open-label, multicenter study of the long-term safety of siltuximab (an anti-interleukin-6 monoclonal antibody) in patients with multicentric Castleman disease. Oncotarget 2015; 6: 30408-19. (Among 19 patients with Castleman disease who responded to siltuximab in a controlled trial and were continued on therapy long term [11 mg/kg every 3 to 6 weeks for an average of 5 years], side effects decreased with prolonged therapy, but included “hepatobiliary disorders” in 42% during the first year, but none thereafter and no patient stopped therapy because of liver test abnormalities). 26327301
Koff JL, Lonial S. Emerging treatments in Castleman disease - a critical appraisal of siltuximab. Biologics 2016; 10: 9-15. (Review of Castleman disease and its therapy including use of siltuximab; no mention of ALT elevations or hepatotoxicity). 26869762

## OTHER REFERENCE LINKS

1. Recent References on Siltuximab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Siltuximab+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Siltuximab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Siltuximab)